# Mavyret

## OVERVIEW

### Introduction

Mavyret is an oral, fixed combination of two antiviral agents, glecaprevir and pibrentasivir used to treat chronic hepatitis C virus (HCV) infection due to any genotype (1 through 6). This combination has not been linked to instances or worsening of serum enzymes during therapy or with de novo appearance of clinically apparent liver injury. However, like all effective direct acting antiviral agents for hepatitis C, Mavyret is considered capable of causing reactivation of hepatitis B in susceptible patients and transient hepatic decompensation in patients with cirrhosis.

### Background

Mavyret is the commercial name for a fixed combination of oral antiviral agents used to treat chronic hepatitis C virus infection of all genotypes (1 through 6). The hepatitis C virus encodes several nonstructural (NS) polypeptides that are essential for its replication, including NS3/4 that has protease and helicase activities, NS5A that is a membrane bound polypeptide that is essential for viral replication and NS5B an HCV specific, RNA-dependent, RNA polymerase. These polypeptides are effective targets for antiviral therapy of hepatitis C. Mavyret is a fixed dose combination of glecaprevir (glek a' pre vir) which is a potent HCV NS3/4 protease inhibitor and pibrentasvir (pi brent' as vir) an HCV NS5A inhibitor. In cell culture, each of these agents has potent activity against all genotypes of HCV, but antiviral resistance can arise rapidly with continued exposure to a single agent. The combination of these two direct acting agents with different molecular targets allows for a sustained viral suppression while avoiding antiviral resistance. The combination of glecaprevir and pibrentasvir was shown to be very effective in suppressing HCV replication in patients infected with all 6 HCV genotypes and to result in sustained virological responses (SVR) and eradication of HCV in more than 95% of patients when given for 8 weeks or more. Mavyret was approved for use in the United States in 2017, the fifth all-oral antiviral combination to receive approval for chronic hepatitis C. It is available as tablets in a fixed dose combination of 100 mg of glecaprevir and 40 mg of pibrentasvir. The recommended dose in adults is 3 tablets once daily for 8 weeks in patients without cirrhosis and for 12 weeks in those with compensated (Class A) cirrhosis. Longer courses of therapy (12 or 16 weeks) are recommended for patients previously treated with HCV NS3/4 protease inhibitors or NS5A inhibitors. Mavyret has not been approved for use in patients with decompensated cirrhosis. Side effects are uncommon but are generally mild and can include fatigue, headache and nausea.

### Hepatotoxicity

In large randomized controlled trials, serum aminotransferase levels decreased rapidly during Mavyret therapy and there were only rare instances of late, de novo elevations in ALT or AST that were usually mild-to-moderate in degree and rising to more than 5 times ULN in less than 1% of treated subjects. In addition, Mavyret has been linked to only rare instances of hepatic decompensation during treatment of patients with preexisting cirrhosis (<1%) and possibly with instances of reactivation of hepatitis B, two rare but potentially serious complications that have been linked to other oral regimens to treat chronic hepatitis C. Episodes of decompensation typically arise after 2 to 6 weeks of treatment and are marked by symptoms of fatigue, pruritus and jaundice with marked elevations in serum bilirubin, but minimal increase in serum aminotransferase and alkaline phosphatase levels. Mavyret is not approved for use in patients with advanced cirrhosis (Child Class B or C). The product label for Mavyret has a boxed warning for reactivation of hepatitis B, and screening for HBsAg and anti-HBc is recommended before starting therapy, with careful monitoring during treatment if these markers are present.

Likelihood score: C (rare cause of clinically apparent liver injury due to transient hepatic decompensation or reactivation of hepatitis B).

### Mechanism of Injury

The mechanism by which glecaprevir and pibrentasvir might cause liver injury is not known. Both are metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 1A2, and liver injury may be due to production of a toxic or immunogenic metabolite. Mavyret is also susceptible to drug-drug interactions with strong inducers or inhibitors of CYP 3A4.

### Outcome and Management

While 8 to 16 weeks of therapy with Mavyret can be associated with transient mild-to-moderate serum aminotransferase elevations, it has not been convincingly linked to cases of clinically apparent idiosyncratic liver injury. Nevertheless, Mavyret is labelled as having the potential of causing decompensation of preexisting cirrhosis and reactivation of hepatitis B in susceptible patients. Assessment of patients for cirrhosis and screening for HBsAg and anti-HBc is recommended before treatment with Mavyret. Patients with markers of ongoing (HBsAg) or previous (anti-HBc) hepatitis B virus infection should be monitored for HBV DNA levels before and at 4 week intervals during therapy. Initiation of oral antiviral therapy for hepatitis B is warranted if levels of HBV DNA rise significantly. In addition, Mavyret should be permanently discontinued if jaundice or symptoms of liver injury arise, or if serum ALT or AST levels are persistently above 5 times the ULN.

Drug Class: Antiviral Agents, Hepatitis C Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Glecaprevir, Pibrentasvir – Mavyret®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mavyret)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Glecaprevir | 1365970-03-1 | C38-H46-F4-N6-O9-S
Pibrentasvir | 1353900-92-1 | C57-H65-F5-N10-O8 | SID:252163521

## ANNOTATED BIBLIOGRAPHY

References updated: 07 February 2022

Abbreviations: HCV, hepatitis C virus; DAA, direct acting antiviral agent; SVR, sustained virological response; ULN, upper limit of the normal range.

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013; does not discuss oral, direct acting antiviral agents used to treat hepatitis C).
European Association for Study of Liver. (2015). EASL Recommendations on treatment of hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
Gane E, Poordad F, Wang S, Asatryan A, Kwo PY, Lalezari J, Wyles DL, et al. (2016). High Efficacy of ABT-493 and ABT-530 treatment in patients with HCV genotype 1 or 3 infection and compensated cirrhosis. Gastroenterology. (Among 82 cirrhotic patients with chronic HCV infection genotypes 1 or 3 who were treated with glecaprevir and pibrentasvir for 12 or 16 weeks with or without ribavirin, the overall SVR rate was 98% and no patient developed hepatic decompensation).
Kwo PY, Poordad F, Asatryan A, Wang S, Wyles DL, Hassanein T, Felizarta F, et al. (2017). Glecaprevir and pibrentasvir yield high response rates in patients with HCV genotype 1-6 without cirrhosis. J Hepatol. (Among 449 noncirrhotic patients with chronic HCV infection of all genotypes treated with glecaprevir and pibrentasvir with or without ribavirin for 8 or 12 weeks in 2 open label trials, SVR rates were excellent [97-100%], except in patients with genotype 3 [83-94%], and there were no ALT elevations after the initial decreases from baseline).
Poordad F, Felizarta F, Asatryan A, Sulkowski MS, Reindollar RW, Landis CS, Gordon SC, et al. (2017). Glecaprevir and pibrentasvir for 12 weeks for hepatitis C virus genotype 1 infection and prior direct-acting antiviral treatment. Hepatology. (Among 91 noncirrhotic patients with chronic HCV infection, genotype 1, previously treated with NS3/4 or NS5A inhibitors, who received glecaprevir and pibrentasvir, SVR rates were 86-100% and there were no liver related serious adverse events or ALT elevations above 3 times ULN).
AASLD. http://www.hcvguidelines.org/ (Guidelines for therapy of hepatitis C maintained and regularly updated by the American Association for the Study of Liver Diseases [AASLD] and the Infectious Diseases Society of America [IDSA]).
Gane E, Lawitz E, Pugatch D, Papatheodoridis G, Bräu N, Brown A, Pol S, et al. (2017). Glecaprevir and pibrentasvir in patients with HCV and severe renal impairment. N Engl J Med. (Among 104 patients with chronic hepatitis C [any genotype] and severe renal dysfunction [82% on dialysis] treated with glecaprevir and pibrentasvir for 12 weeks, the SVR rate was 98% and no patient developed hepatic decompensation or ALT elevations above 3 times ULN).
Forns X, Lee SS, Valdes J, Lens S, Ghalib R, Aguilar H, Felizarta F, et al. (2017). Glecaprevir plus pibrentasvir for chronic hepatitis C virus genotype 1, 2, 4, 5, or 6 infection in adults with compensated cirrhosis (EXPEDITION-1): a single-arm, open-label, multicentre phase 3 trial. Lancet Infect Dis. (Among 146 patients with compensated cirrhosis due to chronic hepatitis C [genotypes 1, 2, 4, 5 and 6] treated with glecaprevir and pibrentasvir for 12 weeks, 99% had an SVR, while 11 patients [8%] had a serious adverse event, but none had late ALT elevations above 5 times ULN or hepatic decompensation).
(2017). Mavyret and Vosevi--two new combinations for chronic HCV infection. Med Lett Drugs Ther. (Concise review of mechanism of action, clinical efficacy, safety and costs of Mavyret; mentions that common adverse effects are headache, fatigue and nausea and that the product label has a boxed warning of HBV reactivation).
Asselah T, Kowdley KV, Zadeikis N, Wang S, Hassanein T, Horsmans Y, Colombo M, et al. (2018). Efficacy of glecaprevir/pibrentasvir for 8 or 12 Weeks in patients with hepatitis C virus genotype 2, 4, 5, or 6 infection without cirrhosis. Clin Gastroenterol Hepatol. (Among 526 patients with chronic hepatitis C, genotypes 2, 4, 5 and 6, treated with Mavyret, SVR rates were 93-98% with 8 weeks and 99% with 12 weeks, ALT elevations above 5 times ULN occurred in 3 subjects, one becoming jaundiced at week 12, but resolving completely within 2 weeks of discontinuation and accompanied by an SVR).
Chayama K, Suzuki F, Karino Y, Kawakami Y, Sato K, Atarashi T, Naganuma A, et al. (2018). Efficacy and safety of glecaprevir/pibrentasvir in Japanese patients with chronic genotype 1 hepatitis C virus infection with and without cirrhosis. J Gastroenterol. (Among 129 Japanese noncirrhotic patients with chronic hepatitis C, genotype 1, treated with glecaprevir/pibrentasivir for 8 weeks, the SVR rate was 99%, while among 38 cirrhotic patients treated for 12 weeks the SVR rate was 100%).
Zeuzem S, Foster GR, Wang S, Asatryan A, Gane E, Feld JJ, Asselah T, et al. (2018). Glecaprevir-pibrentasvir for 8 or 12 weeks in HCV genotype 1 or 3 infection. N Engl J Med. (Among 1208 patients with chronic hepatitis C without cirrhosis who were treated with glecaprevir and pibrentasvir for 8 or 12 weeks, SVR rates were 99% with 8 weeks of therapy in genotype 1 and 95% with 8 or 12 weeks of therapy in genotype 3 infected patients and there were no ALT elevations above 5 times ULN, no instances of decompensated liver disease or early termination of therapy for hepatic adverse events).
Poordad F, Pol S, Asatryan A, Buti M, Shaw D, Hézode C, Felizarta F, et al. (2018). Glecaprevir/pibrentasvir in patients with HCV genotype 1 or 4 and prior direct-acting antiviral treatment failure. Hepatology. (Among 91 patients with chronic hepatitis C, genotypes 1 and 4, who had failed previous DAA therapy and were treated with glecaprevir and pibrentasvir, SV rates were 89% with 12 weeks and 91% for 16 weeks, relapse occurring only in those with previous exposure to NS5A inhibitors; there were no ALT elevations above 5 times ULN during therapy, but 3 patients were found to have liver cancer within 12 weeks of completing treatment).
Wyles D, Poordad F, Wang S, Alric L, Felizarta F, Kwo PY, Maliakkal B, et al. (2018). Glecaprevir/ pibrentasvir for hepatitis C virus genotype 3 patients with cirrhosis and/or prior treatment experience: A partially randomized phase 3 clinical trial. Hepatology. (Among 131 patients with chronic hepatitis C, genotype 3, with cirrhosis or previous failure of antiviral therapy who received glecaprevir and pibrentasvir, the SVR rate was 91% with 12 weeks and 96% with 16 weeks of treatment, the differences being largely among those with previous therapy; no patient had a late increase in ALT levels or episode of hepatic decompensation).
Rockstroh JK, Lacombe K, Viani RM, Orkin C, Wyles D, Luetkemeyer AF, Soto-Malave R, et al. (2018). Efficacy and safety of glecaprevir/pibrentasvir in patients co-infected with hepatitis C virus and human immunodeficiency virus-1: the EXPEDITION-2 Study. Clin Infect Dis. (Among 153 patients with chronic hepatitis C [genotype 1 to 6] who were coinfected with HIV and were treated with glecaprevir and pibrentasvir for 8 or 12 weeks, SVR rates were 98% with either duration of treatment, and there were no ALT or AST elevations above 3 times ULN or instances of decompensated liver disease).
Garrison KL, German P, Mogalian E, Mathias A. (2018). The drug-drug interaction potential of antiviral agents for the treatment of chronic hepatitis C infection. Drug Metab Dispos. (Extensive summary of drug-drug interactions of the drugs used to treat chronic hepatitis C; Glecaprevir and pibrentasvir are substrates of P-glycoprotein [Pgp] and weak inhibitors of Pgp, CYP3A, CYP1A2 and UGT1A1).
Caroleo B, Caroleo MC, Cimellaro A, Colangelo L, Perticone M, Di Mizio G, De Sarro G, et al. (2019). Glecaprevir/ pibrentasvir induced cholestatic jaundice in a HCV patient with renal failure. a case presentation. Curr Drug Saf. (86 year old man with chronic hepatitis C and possible cirrhosis developed jaundice within 4 weeks of starting Mavyret [bilirubin 5.8 mg/dL, ALT 43 U/L, GGT 34 U/L, INR and albumin normal], which resolved within 1 month of stopping and patient was HCV RNA negative in follow up).
Hammami MB, Aboushaar R, Alsabbagh E. (2019). Glecaprevir/pibrentasvir-associated acute liver injury in non-cirrhotic, chronic HCV infection without HBV co-infection. BMJ Case Rep. (A 53 year old woman with chronic hepatitis C without cirrhosis developed jaundice 2-3 weeks after starting Mavyret [bilirubin 6.8 mg/dL, ALT 974 U/L, Alk P 177 U/L, INR 1.2], symptoms resolving within a week of stopping and with normal liver tests and no detectable HCV RNA in serum in follow up).
Yoon JH, Kim SM, Kang G, Kim HJ, Jun CH, Choi SK. (2019). A case report of glecaprevir/pibrentasvir-induced severe hyperbilirubinemia in a patient with compensated liver cirrhosis. Medicine (Baltimore). (77 year old man with chronic hepatitis C, cirrhosis, a history of hepatocellular cancer and tuberculosis developed jaundice 3 weeks after starting Mavyret [bilirubin 21.6 mg/dL, ALT normal], which resolved within a few weeks of stopping therapy; in follow up he was HCV RNA negative and bilirubin fell to 1.2 mg/dL).
Persico M, Aglitti A, Milella M, Coppola C, Messina V, Claar E, Gentile I, et al. (2019). Real-life glecaprevir/pibrentasvir in a large cohort of patients with hepatitis C virus infection: The MISTRAL study. Liver Int. (Among 1177 patients with chronic hepatitis C enrolled in an observational study of therapy with Mavyret, the overall SVR was 99% and adverse event rate was 5.2% with 6 serious adverse events, two of which were jaundice).
Gane E, Poordad F, Zadeikis N, Valdes J, Lin CW, Liu W, Asatryan A, et al. (2019). Safety and pharmacokinetics of glecaprevir/pibrentasvir in adults with chronic genotype 1-6 hepatitis C virus infections and compensated liver disease. Clin Infect Dis. (Among 2369 patients with chronic hepatitis C treated with Mavyret for 8-16 weeks in 9 clinical trials, the 308 with cirrhosis compared to those without had similar rates of SVR [96% vs 97.5%], adverse events [74% vs 67%], serious adverse events [6% vs 2%], ALT elevations above 5 times ULN [0% vs <1%]; and one patient with cirrhosis and esophageal varices had a variceal bleed without evidence of hepatic worsening on day 22 and continued therapy and achieved an SVR).
Brown RS, Buti M, Rodrigues L, Chulanov V, Chuang WL, Aguilar H, Horváth G, et al. (2020). Glecaprevir/pibrentasvir for 8 weeks in treatment-naïve patients with chronic HCV genotypes 1-6 and compensated cirrhosis: The EXPEDITION-8 trial. J Hepatol. (Among 343 patients with chronic hepatitis C and compensated cirrhosis treated with Mavyret for 8 weeks, the overall SVR rate was 98%, and 46% had adverse events, 2% serious, no patient developed hepatic decompensation, and only one had an isolated single elevation of ALT above 5 times ULN).
Liu YC, Jeng WJ, Cheng YT, Hsieh YC, Teng W, Chen YC, Lin CY, et al. (2020). Incidence and predictors for abnormal liver function during direct-acting antiviral agents in chronic hepatitis C patients. Medicine (Baltimore). (Among 1563 patients with chronic hepatitis C treated with direct acting antiviral agents between 2015 -2019 at a single referral center in Taiwan, the SVR rate was 98% and on treatment ALT elevations arose in 11%, with higher rates in those with cirrhosis, with elevated levels pre-treatment, and those receiving asunaprevir with daclatasvir [40%], compared to Zepatier [12.3%], sofosbuvir-based regimens [11.6%] and Mavyret [5.4%]; on treatment ALT elevations were not associated with a lower SVR rate).
Aghemo A, Alberti A, Andreone P, Angelico M, Brunetto MR, Chessa L, Ciancio A, et al., MARS Study Group. (2021). Effectiveness and safety of glecaprevir/pibrentasvir in chronic hepatitis C patients: Results of the Italian cohort of a post-marketing observational study. Dig Liver Dis. (Among 321 patients with chronic hepatitis C treated with Mavyret followed in a postmarketing observational study, the SVR rate in those with follow up was 99% and adverse event rate 9%, which were serious in 1.2%, one patient developing ascites).
Wedemeyer H, Erren P, Naumann U, Rieke A, Stoehr A, Zimmermann T, Lohmann K, et al. (2021). Glecaprevir/pibrentasvir is safe and effective in hepatitis C patients with cirrhosis: Real-world data from the German Hepatitis C-Registry. Liver Int. (Among 182 patients with chronic hepatitis C and cirrhosis who were treated with Mavyret and followed in a prospective observation study, the SVR rate was 100% in patients with follow up and serious adverse events arose in 4% including 1 patient with liver transplant, 1 with hepatic decompensation, and 4 with ALT elevations above 3 times ULN).
Forns X, Feld JJ, Dylla DE, Pol S, Chayama K, Hou J, Heo J, et al. (2021). Safety of patients with hepatitis C virus treated with glecaprevir/pibrentasvir from clinical trials and real-world cohorts. Adv Ther. (Among 5106 patients with chronic hepatitis C treated with Mavyret in clinical trials or postmarketing observational studies, the overall SVR rate was 97.5% and adverse event rate in clinical trials was 61%, scored as serious in 1.7%; ALT elevations above 5 times ULN arose in 0.2% and 2 patients developed jaundice with ALT elevations and 1 patient [with preexisting cirrhosis) had hepatic decompensation).
Klinker H, Naumann U, Rössle M, Berg T, Bondin M, Lohmann K, Koenig B, et al. (2021). Glecaprevir/pibrentasvir for 8 weeks in patients with compensated cirrhosis: safety and effectiveness data from the German Hepatitis C-Registry. Liver Int. (Among 148 patients with chronic hepatitis C and cirrhosis who were treated with Mavyret and enrolled in a German Registry, the SVR rate was 98% among those with follow up and no patient had a drug-related severe adverse event, although one developed jaundice which persisted after stopping and despite an SVR).
Hara T, Ohara T, Taniguchi M, Sakai H, Oka K, Iwai N, Tsuji T, et al. (2021). Severe liver injury associated with glecaprevir plus pibrentasvir therapy in a patient with treatment-naïve hepatitis C virus infection. Intern Med. (49 year old Japanese man with chronic hepatitis C, HBsAg carrier state and history of alcoholism developed jaundice 6 weeks after starting Mavyret [pre-treatment bilirubin 1.4 rising to 20.6 mg/dL, ALT 50 to 65 U/L, AST 100 to 205 U/L, Alk P 436 to 442 U/L, INR 1.2, HBV DNA remaining negative] and evidence of hepatic encephalopathy, but ultimately recovered and was HCV RNA negative).
Torgersen J, Newcomb CW, Carbonari DM, Rentsch CT, Park LS, Mezochow A, Mehta RL, et al. (2021). Protease inhibitor-based direct-acting antivirals are associated with increased risk of aminotransferase elevations but not hepatic dysfunction or decompensation. J Hepatol. (Among propensity matched subgroups of 71,391 adults with chronic hepatitis C treated in the Veterans Administration Medical system with oral, direct acting antiviral agents, patients with higher baseline fibrosis scores compared to those with lower scores were more likely to have serum ALT elevations [>200 U/L] [0.5% vs 0.3%] and hepatic decompensation [0.41% vs 0.03%], and ALT elevations were more frequent with Viekira Pak and Technive [1.1-1.2%] compared to Mavyret, Zepatier, Epclusa, and Harvoni [0.11-0.39%]).
Huang CF, Kuo HT, Chang TS, Lo CC, Hung CH, Huang CW, Chong LW, et al. (2021). Nationwide registry of glecaprevir plus pibrentasvir in the treatment of HCV in Taiwan. Sci Rep. (Among 3144 patients with chronic hepatitis C treated with Mavyret and enrolled in a nationwide Taiwanese HCV registry, the SVR rate was 99% and adverse events included ALT elevations in 2%, but most were mild and transient, only 0.6% were above 5 times ULN, and no patient developed clinically apparent liver injury or hepatic decompensation).

## OTHER REFERENCE LINKS

1 Recent References on Mavyret: from PubMed.gov2. (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Mavyret/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D)) Trials on Mavyret: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mavyret)